# Azacitidine

## OVERVIEW

### Introduction

Azacitidine is a cytosine analogue and antineoplastic agent used in the therapy of myelodysplastic syndromes. Azacitidine is associated with a low rate of transient serum enzyme elevations during therapy and has not been convincingly implicated in cases of clinically apparent acute liver injury with jaundice.

### Background

Azacitidine (ay" za sye' ti deen: also spelled azacytidine) is a pyrimidine analogue (5-azacytidine) which is converted intracellularly to a triphosphate which becomes incorporated into RNA and DNA. While azacitidine has anticancer effects, it proved to have limited usefulness in solid tumors and lymphomas. In low doses, azacitidine inhibits methylation of DNA and results in the expression of silenced genes, including tumor suppressor genes. Studies done in vitro and in vivo have shown that azacitidine induces differentiation of bone marrow cells and results in normalization of bone marrow in a proportion of patients with myelodysplasia. Azacitidine was approved for use in the United States in 2004 and the current single indication is for therapy of myelodysplastic syndromes. It is also under evaluation as therapy of acute myelogenous leukemia. Azacitidine is available as a powder for injection in 100 mg vials under the trade name of Vidaza. The usual initial dosage regimen in adults is 75 mg/m^2^ body surface area subcutaneously or intravenously each day for 7 days, with repeat courses after 28 days. A minimum of 4 courses is recommended and the dose can be increased to 100 mg/m^2^ based upon tolerance and response. An oral form of azacitidine was approved in 2021 as maintenance therapy in patients with acute myelogenous leukemia after a first remission. Oral azacitidine is available in tablets of 200 and 300 mg under the brand name Onureg, the recommended dose being 300 mg on days 1 to 14 in 28-day cycles. Common side effects include bone marrow suppression, nausea, vomiting, diarrhea, stomatitis, bruising, abdominal pain, myalgias, headache, dizziness, fatigue, fever, rash and pruritus. Uncommon but potentially severe adverse events include severe myelosuppression, febrile neutropenia, pneumonitis, sepsis, tumor-lysis syndrome, and embryo-fetal toxicity.

### Hepatotoxicity

In clinical trials, serum enzyme elevations occurred in up to 16% of patients on azacitidine therapy for cancer or myelodysplasia who had concurrent, underlying liver disease or liver metastases, but rarely in persons without a preexisting hepatic illness. In subsequent studies, liver adverse reactions attributed to azacitidine have rarely been reported, at least when it is given in conventional doses. Nevertheless, monitoring of serum enzyme levels is recommended in treating patients who have concurrent liver disease. Cases of clinically apparent liver injury attributed to azacitidine in patients without underlying liver disease have not been reported in the literature.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury, particularly in persons with pre-existing liver disease).

### Mechanism of Injury

Hepatotoxicity from azacitidine appears to be rare and confined mostly to patients with underlying liver disease. For these reasons, the liver injury is likely due to direct toxicity.

### Outcome and Management

The severity of the liver injury linked to azacitidine therapy is usually mild-to-moderate in severity occurring in patients with preexisting liver disease. Azacitidine has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between azacitidine and other nucleoside or cytidine analogues.

Drug Class: Antineoplastic Agents

Other drugs for myelodysplastic syndromes: Decitabine, Decitabine/Cedazuridine, Luspatercept

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Azacitidine (powder for solution) – Vidaza®

Azacitidine (oral tablet) – Onureg®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Azacitidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Azacitidine | 320-67-2 | C8-H12-N4-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 27 July 2023

Abbreviations: AML, acute myelogenous leukemia; CMML, chronic myelomonocytic leukemia; iv, intravenous; MDS, myelodysplastic syndrome; sc, subcutaneously.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that azacitidine can cause serum aminotransferase elevations, but has been considered not very hepatotoxic).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3nd ed. Amsterdam: Elsevier, 2013, p. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; azacitidine is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1203-36. (Textbook of pharmacology and therapeutics states that azacitidine like decitabine induce differentiations of cells by inhibition of DNA cytosine methyltransferase activity and both are used to treat myelodysplasia).
Weiss AJ, Stambaugh JE, Mastrangelo MJ, Laucius JF, Bellet RE. Phase I study of 5-azacytidine (NSC-102816). Cancer Chemother Rep 1972; 56: 413-9. (Among 30 patient with advanced malignancies treated with azacitidine [0.5 to 1.4 mg/kg/day] for 10-15 days, reversible rises in AST but no other liver abnormalities occurred in several patients). 19051503
Bellet RE, Mastrangelo MJ, Engstrom PF, Custer RP. Hepatotoxicity of 5-azacytidine (NSC-102816) (a clinical and pathologic study). Neoplasma 1973; 20: 303-9. (Among 20 patients with various malignancies treated with azacitidine [0.8-2.2 mg/kg/day] for 10 days, liver adverse events occurred in 7 patients, 4 of whom developed jaundice and died of rapidly progressive hepatic coma, all 4 having hepatic metastatic disease and low serum albumin levels before azacitidine therapy). 4125219
Weiss AJ, Metter GE, Nealon TF, Keanan JP, Ramirez G, Swaiminathan A, Fletcher WS, et al. Phase II study of 5-azacytidine in solid tumors. Cancer Treat Rep 1977; 61: 55-8. (177 patients with advanced cancer or lymphoma were treated with azacitidine [1.6 mg/kg/day] for 10 days, followed by a rest period and then infusions every 2 weeks for 8 weeks; "hepatic failure" occurred in 7% of 150 who received it by rapid intravenous infusion, but in none of 27 in whom it was given by slow infusion). 67894
Armitage JO, Burns CP. Treatment of refractory adult acute nonlymphoblastic leukemia with subcutaneous 5-azacytidine. Cancer Treat Rep 1977; 61: 1721-3. (Among 10 patients with refractory leukemia in a pilot study of subcutaneous azacitidine, 3 had mild elevations in bilirubin and AST which resolved promptly after each course). 74285
Vélez-Garcia E, Vogler WR, Bartolucci AA, Arkun SN. Twice weekly 5-azacytidine infusion in dissmeinated metastatic cancer: a phase II study. Cancer Treat Rep. 1977;61:1675-7. (Among 91 patients with metastatic cancer or refractory lymphoma treated with intravenous infusions of azacitidine, one patient had minor degrees of "hepatic dysfunction"). 74283
Bellet RE, Catalano RB, Mastrangelo MJ, Berd D. Phase II study of subcutaneously administered 5-azacytidine (NSC-102816) in patients with metastatic malignant melanoma. Med Pediatr Oncol 1978; 4: 11-5. (Among 30 patients with metastatic melanoma treated with azacitidine [100 mg/m2/day] for 10 days, with repeated courses at 35 day intervals; side effects included nausea, vomiting, alopecia, diarrhea rash and pruritus: "there was no evidence of hepatic ... toxicity"). 75498
Peterson BA, Bloomfield CD, Gottlieb AJ, Coleman M, Greenberg MS. 5-azacitidine and zorubicin for patients with previously treated acute nonlymphocytic leukemia: a Cancer and Leukemia Group B pilot study. Cancer Treat Rep 1982; 66: 563-6. (Among 29 patients with refractory leukemia treated with azacitidine and zorubicin [an anthracycline similar to doxorubicin], toxicity was severe, 15 patients developed liver test abnormalities, 5 became jaundiced, and one died of suspected hepatic failure). 6174230
Sznol M, Ohnuma T, Holland JF. Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis 1987; 7: 237-56. (Review describes azacitidine as a pyrimidine analogue with activity in acute leukemia; "there is scant evidence of azacitidine hepatotoxicity"). 3317861
Silverman LR, Demakos EP, Peterson BL, Kornblith AB, Holland JC, Odchimar-Reissig R, Stone RM, et al. Randomized controlled trial of azacitidine in patients with the myelodysplastic syndrome: a study of the cancer and leukemia group B. J Clin Oncol 2002; 20: 2429-40. (Among 191 patients with myelodysplasia treated with azacitidine or supportive care, response rates and survival were greater with azacitidine and the major toxicity was hematologic; no mention of ALT elevations or liver injury). 12011120
Kaminskas E, Farrell AT, Wang YC, Sridhara R, Pazdur R. FDA drug approval summary: azacitidine (5-azacytidine, Vidaza) for injectable suspension. Oncologist 2005; 10: 176-82. (Summary of the efficacy and safety results that led to the approval of azacitidine as therapy for myelodysplastic syndromes of all types; "liver function abnormalities occurred, for the most part, in patients with intercurrent illnesses, including hepatobiliary disorders. More severe abnormalities occurred in patients with previously diagnosed liver cirrhosis"). 15793220
Vigil CE, Martin-Santos T, Garcia-Manero G. Safety and efficacy of azacitidine in myelodysplastic syndromes. Drug Des Devel Ther 2010; 4: 221-9. (Review of the mechanism of action, pharmacokinetics, efficacy and safety of azacitidine; mentions that caution should be used in treating patients who have hepatic dysfunction, because early studies reported liver injury and hepatic coma in patients with liver metastases).
Santini V, Fenaux P, Mufti GJ, Hellströindberg E, Silverman LR, List A, Gore SD, et al. Management and supportive care measures for adverse events in patients with myelodysplastic syndromes treated with azacitidine*. Eur J Haematol 2010; 85: 130-8. (Review of side effects of azacitidine and their management; the most common adverse events are bone marrow suppression, gastrointestinal complaints and injection site reactions; no mention of ALT elevations or liver toxicity). 20394651
Garcia-Manero G, Gore SD, Cogle C, Ward R, Shi T, Macbeth KJ, Laille E, et al. Phase I study of oral azacitidine in myelodysplastic syndromes, chronic myelomonocytic leukemia, and acute myeloid leukemia. J Clin Oncol 2011; 29: 2521-7. (Phase 1 study of oral doses of azacitidine after an initial subcutaneous course in 41 patients with CML; oral doses were escalated to tolerance; dose limiting side effects included nausea and diarrhea; no mention of ALT abnormalities or liver injury). 21576646
Breccia M, Loglisci G, Salaroli A, Serrao A, Petrucci L, Mancini M, Alimena G. 5-azacitidine efficacy and safety in patients aged >65 years with myelodysplastic syndromes outside clinical trials. Leuk Lymphoma 2012; 53: 1558-60. (Open label study of azacitidine in 38 elderly patients with myelodysplasia; common side effects were cytopenia, gastrointestinal upset and rash; no mention of ALT elevations or liver toxicity). 22280532
Pollyea DA, Kohrt HE, Gallegos L, Figueroa ME, Abdel-Wahab O, Zhang B, Bhattacharya S, et al. Safety, efficacy and biological predictors of response to sequential azacitidine and lenalidomide for elderly patients with acute myeloid leukemia. Leukemia 2012; 26: 893-901. (Open label study of azacitidine followed by lenalidomide in 18 elderly patients with acute myeloid leukemia; side effects included bone marrow suppression, neutropenic fever, fatigue, nausea and vomiting; no mention of ALT elevations or hepatotoxicity). 22033493
Lee YG, Kim I, Yoon SS, Park S, Cheong JW, Min YH, Lee JO, et al. Comparative analysis between azacitidine and decitabine for the treatment of myelodysplastic syndromes. Br J Haematol 2013; 161: 339-47. (Observational study comparing safety and efficacy of azacitidine vs decitabine in 300 Korean patients with myelodysplasia, found similar rates of efficacy and side effects; no mention of ALT elevations or hepatotoxicity). 23432512
Pleyer L, Burgstaller S, Girschikofsky M, Linkesch W, Stauder R, Pfeilstocker M, Schreder M, et al. Azacitidine in 302 patients with WHO-defined acute myeloid leukemia: results from the Austrian Azacitidine Registry of the AGMT-Study Group. Ann Hematol 2014; 93: 1825-38. (Among 302 Austrian patients with acute myeloid leukemia treated with azacitidine the overall response rate was 48% and serious adverse events were common, but mostly hematologic; serum enzyme elevations were recorded in 4 patients, but there were no deaths from liver disease). 24951123
Dombret H, Seymour JF, Butrym A, Wierzbowska A, Selleslag D, Jang JH, Kumar R, et al. International phase 3 study of azacitidine vs conventional care regimens in older patients with newly diagnosed AML with >30% blasts. Blood 2015; 126: 291-9. (Among 488 patients with acute myeloid leukemia treated with azacitidine or conventional care regimens, median overall survival was longer with azacitidine [10.4 vs 6.5 months] and adverse events were frequent in both groups; no mention of ALT elevations, hepatotoxicity or liver related deaths). 25987659
Grinblatt DL, Sekeres MA, Komrokji RS, Swern AS, Sullivan KA, Narang M. Patients with myelodysplastic syndromes treated with azacitidine in clinical practice: the AVIDA registry. Leuk Lymphoma 2015; 56: 887-95. (Among 421 patients with myelodysplastic syndromes treated with azacitidine enrolled in a US registry and followed for an average of 8 months, adverse events were mostly cytopenias; no mention of ALT elevations or hepatotoxicity and no discontinuations for liver related adverse events). 24956145
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none to azacitidine). 25754159
Scott LJ. Azacitidine: A review in myelodysplastic syndromes and acute myeloid leukaemia. Drugs 2016; 76: 889-900. (Review of the mechanism of action, pharmacology, clinical efficacy and safety of azacitidine; mentions that non-hematologic adverse events include diarrhea, constipation, nausea, skin rash and injection reactions; no mention of liver related adverse events). 27193945
Salim O, Toptas T, Avsar E, Yucel OK, Ozturk E, Ferhanoglu B, Geduk A, et al. Azacitidine versus decitabine in patients with refractory anemia with excess blast-Results of multicenter study. Leuk Res 2016; 45: 82-9. (Among 88 Turkish patients with refractory anemia treated with azacitidine or decitabine, response rates were similar as were overall survival and adverse event rates; no mention of ALT elevations, hepatotoxicity or non-hematologic adverse events). 27107658
Pappa V, Anagnostopoulos A, Bouronikou E, Briasoulis E, Kotsianidis I, Pagoni M, Zikos P, et al. A retrospective study of azacitidine treatment in patients with intermediate-2 or high risk myelodysplastic syndromes in a real-world clinical setting in Greece. Int J Hematol 2017; 105: 184-95. (Among 88 Greek patients with myelodysplastic syndromes treated with azacitidine and followed in 17 hospitals, 42% had at least one serious adverse event, but most were cytopenias and none were liver related). 27815858
Savona MR, Kolibaba K, Conkling P, Kingsley EC, Becerra C, Morris JC, Rifkin RM et al. Extended dosing with CC-486 (oral azacitidine) in patients with myeloid malignancies. Am J Hematol. 2018;93:1199-1206. (Among 31 patients enrolled in an extension study of oral azacitidine [300 mg for 21 days in each 28-day cycle], the overall response rate was 29% and adverse events were mostly gastrointestinal and hematologic; no mention of ALT elevations or hepatotoxicity). 30016552
Morita Y, Maeda Y, Yamaguchi T, Urase F, Kawata S, Hanamoto H, Tsubaki K, et al. Five-day regimen of azacytidine for lower-risk myelodysplastic syndromes (refractory anemia or refractory anemia with ringed sideroblasts): A prospective single-arm phase 2 trial. Cancer Sci. 2018;109(10):3209-3215. (Among 51 adults with lower-risk MDS treated with 5-day regimens of azacytidine, hematologic improvement occurred in 47%, transfusion independence in 29% and complete response in 22%; most severe adverse events were hematologic or infection related, one patient had ALT elevations [2%] but none were above 5 times ULN). 30007103
Helbig G, Chromik K, Woźniczka K, Kopińska AJ, Boral K, Dworaczek M, Koclęga A, et al. Real life data on efficacy and safety of azacitidine therapy for myelodysplastic syndrome, chronic myelomonocytic leukemia and acute myeloid leukemia. Pathol Oncol Res. 2019;25:1175-1180. (Among 83 patients with higher-risk MDS, myelomonocytic leukemia or acute myelogenous leukemia treated with azacytidine, overall response rates ranged from 20-27% and adverse events arose in 46% including 2 patients with ALT, both below 5 times ULN). 30613922
Ades L, Guerci-Bresler A, Cony-Makhoul P, Legros L, Sebert M, Braun T, Delaunay J, et al. A phase II study of the efficacy and safety of an intensified schedule of azacytidine in intermediate-2 and high-risk patients with myelodysplastic syndromes: a study by the Groupe Francophone des Myelodysplasies (GFM). Haematologica. 2019;104:e131-e133. (Among 26 patients with intermediate and high-risk MDS treated with a more intensive schedule of azacitidine [5 day course every 14 days], after 8 cycles, the response rate was 22% and the adverse event profile was similar to that with conventional doses; no mention of ALT elevations or hepatotoxicity). 30381302
Lee BH, Kang KW, Jeon MJ, Yu ES, Kim DS, Choi H, Lee SR, et al. Comparison between 5-day decitabine and 7-day azacitidine for lower-risk myelodysplastic syndromes with poor prognostic features: a retrospective multicentre cohort study. Sci Rep. 2020;10:39. (Among 111 adults with low- or intermediate-risk MDS treated with iv decitabine [20 mg/m^2^ for 5 days] or azacitidine [75 mg/m^2^ for 7 days], overall response rates were higher with decitabine [67% vs 44%] while adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 31913293
Garcia-Manero G, Santini V, Almeida A, Platzbecker U, Jonasova A, Silverman LR, Falantes J, et al. Phase III, randomized, placebo-controlled trial of CC-486 (oral azacitidine) in patients with lower-risk myelodysplastic syndromes. J Clin Oncol. 2021;39:1426-1436. (Among 216 adults with lower-risk MDS treated with oral azacitidine [in 12 cycles of 300 mg daily for 21 of 28 days] or placebo, red cell transfusion independence was achieved in 31% vs 11% and adverse events included neutropenia [47% vs 12%], thrombocytopenia [29% vs 16%], febrile neutropenia [28% vs 10%], and pneumonia [12% vs 9%]; no mention of ALT elevations or hepatotoxicity). 33764805
Wang ES, Montesinos P, Minden MD, Lee JH, Heuser M, Naoe T, Chou WC, et al. Phase 3 trial of gilteritinib plus azacitidine vs azacitidine for newly diagnosed FLT3mut+ AML ineligible for intensive chemotherapy. Blood. 2022;140:1845-1857. (Among 120 adults with AML and FLT3 mutation treated with azacytidine with or without gilteritinib, overall survival was similar [8.9 vs 9.8 months] as was complete response rates [16.2% vs 14.3%], and adverse event rates were similar although AST elevations were more frequent with the combination [25% vs 6.4%], all of which were less than 5 times ULN). 35917453
Xu Y, Guo R, Miao M, Zhang G, Lan J, Jin J. Real-world data on efficacy and safety of azacitidine therapy in chronic myelomonocytic leukemia in China: results from a multicenter, retrospective study. Invest New Drugs. 2022;40:1117-1124. (Among 24 patients with chronic myelomonocytic leukemia treated with 1 to 8 cycles of azacytidine, the overall response rate was 38% and complete response rate 8%, while adverse events included thrombocytopenia [29%], pneumonitis [17%], and fever [13%]; no mention of ALT elevations or severe hepatic adverse events). 35834039
Adès L, Girshova L, Doronin VA, Díez-Campelo M, Valcárcel D, Kambhampati S, Viniou NA, et al. Pevonedistat plus azacitidine vs azacitidine alone in higher-risk MDS/chronic myelomonocytic leukemia or low-blast-percentage AML. Blood Adv. 2022;6:5132-5145. (Among 452 patients with AML or CMML treated with azacytidine with or without pevonedistat event-free survival and serious adverse event rates were similar; no mention of ALT elevations or hepatotoxicity). 35728048
Leisch M, Pfeilstöcker M, Stauder R, Heibl S, Sill H, Girschikofsky M, Stampfl-Mattersberger M, et al. Adverse events in 1406 patients receiving 13,780 cycles of azacitidine within the Austrian Registry of Hypomethylating Agents-a prospective cohort study of the AGMT Study-Group. Cancers (Basel). 2022;14:2459. (Among 1519 patients treated with azacytidine enrolled in an Austrian registry of hypomethylating agents, the most common severe adverse events were febrile neutropenia [33%], pneumonia [57%], fatigue [3.4%], and pyrexia [3.1%], while ALT elevations arose in 39% and were above 5 times ULN in 16%; no mention of clinically apparent liver injury). 35626063
Sekeres MA, Taylor J. Diagnosis and treatment of myelodysplastic syndromes: a review. JAMA. 2022;328:872-880. (Concise review of clinical features, natural history, diagnosis, and management of MDS; adverse events are listed in tables but without mention or discussion of ALT elevations or hepatotoxicity). 36066514
Garcia-Manero G. Myelodysplastic syndromes: 2023 update on diagnosis, risk-stratification, and management. Am J Hematol. 2023;98:1307-1325. (Review of the classification of MDS and risk categorization with an update on management including discussion of hypomethylation agents and luspatercept; no mention of ALT elevations or hepatotoxicity). 37288607
Randall MP, DeZern AE. The management of low-risk myelodysplastic syndromes-current standards and recent advances. Cancer J. 2023;29:152-159. (Review of treatment of low-risk MDS including erythropoietin, iron chelation, lenalidomide, luspatercept and low dose hypomethylating agents; no discussion of hepatotoxicity). 37195771

## OTHER REFERENCE LINKS

Recent References on Azacitidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Azacitidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Azacitidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Azacitidine)